# Flucytosine

## OVERVIEW

### Introduction

Flucytosine is an antifungal agent used to treat severe infections caused by candida and cryptococcus. Flucytosine therapy can cause transient mild-to-moderate serum aminotransferase elevations and has been mentioned as a very rare cause of clinically apparent acute drug induced liver injury.

### Background

Flucytosine (floo sye' toe zeen) is a fluorinated pyrimidine analogue which has potent fungicidal activity. Flucytosine is taken up by fungal cells and converted to fluorouracil, which blocks pyrimidine metabolism and may be converted to metabolites that block DNA synthesis. Human cells do not possess the enzymes to convert flucytosine to these toxic metabolites. Flucytosine is active against several Candidal and Cryptococcal species. Flucytosine was approved for use in the United States in 1971, but has been largely replaced by better tolerated and more potent antifungal agents such as amphotericin and the azoles. Flucytosine is available as tablets of 250 and 500 mg in generic forms and under the brand name of Ancobon. The usual recommended dose is 50 to 150 mg/kg daily in divided doses (usually every six hours) and it is usually used in combination with other antifungal agents, most often amphotericin B. Common side effects include nausea, vomiting, and headache. Rare but severe side effects include bone marrow suppression, renal failure, cardiac arrest and toxic epidermal necrolysis.

### Hepatotoxicity

Transient mild-to-moderate elevations in serum aminotransferase or alkaline phosphatase levels occur in up to 41% of patients treated with flucytosine. The enzyme abnormalities are usually asymptomatic and resolve with stopping flucytosine, and sometimes even with its continuation. Clinically apparent hepatotoxicity is very rare. Instances of acute liver injury and hepatic failure have been mentioned in clinical trials of flucytosine therapy, but few details were provided and no convincing case reports of acute hepatic injury with jaundice have been published.

Likelihood score: D (possible rare cause of clinically apparent liver injury.

### Mechanism of Injury

The cause of serum aminotransferase elevations from flucytosine is unknown. While most flucytosine is excreted unchanged in the urine, a small proportion may be metabolized to fluorouracil, which may which may account for its bone marrow and liver toxicity in high doses.

### Outcome and Management

The severity of the liver injury ranges from mild and transient enzyme elevations to clinically apparent liver injury in very rare cases. Typically, serum aminotransferase abnormalities improve rapidly upon discontinuation. Flucytosine has not been definitively implicated in cases of acute liver failure, chronic hepatitis or chronic vanishing bile duct syndrome. Studies of rechallenge have not been reported.

Drug Class: Antifungal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flucytosine – Generic, Ancobon®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=flucytosine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Flucytosine | 2022-85-7 | C4-H4-F-N3-O | Flucytosine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2018

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999; mentions that transient serum enzyme elevations occur in 5-10% of patients treated with flucytosine, and a single case report of severe hepatitis attributed to flucytosine has been published).
Moseley RH. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 473. (Review of hepatotoxicity of antifungal agents mentions that asymptomatic liver chemistry abnormalities occur in up to 41% of patients, and severe liver injury has been reported in two patients).
Bennett JE. Antimicrobial agents: antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-92. (Textbook of pharmacology and therapeutics).
Record CO, Skinner JM, Sleight P, Speller DCE. Candida endocarditis treated with 5-fluorocytosine. Br Med J 1971; 1: 262-4. (3 patients with candida endocarditis were treated with flucytosine and amphotericin B, one recovered, two died, both with patchy hepatic necrosis on autopsy, but without major aminotransferase elevations or jaundice). 5212581
Steer PL, Marks MI, Klite PD. 5-fluorocytosine oral antifungal compound: a report on clinical and laboratory experience. Ann Intern Med 1972; 76: 15-22. (Experience in treating 17 patients with invasive fungal infections with flucytosine; two patients developed ALT elevations [3-5 times normal], one resolving with dose reduction and one with discontinuation; both rapidly). 5063168
Harder EJ, Hermans PE. Treatment of fungal infections with flucytosine. Arch Intern Med 1975; 135: 231-7. (Experience in treating 20 patients with invasive fungal infections with flucytosine alone or with amphotericin B; 6 patients [30%] had “slight” elevations in Alk P and 2 in AST levels, which became normal when flucytosine was stopped). 1096840
Diasio RB, Lakings DE, Bennett JE. Evidence for conversion of 5-fluorocytosine to 5-fluorouracil in humans: possible factor in 5-fluorocytosine clinical toxicity. Antimicrob Agents Chemother 1978; 14: 903-8. (Significant levels of 5-fluorouracil was found in 41 serum samples from patients receiving flucytosine for fungal infections; levels similar to those in patients on cancer chemotherapy). 742878
Bennett JE, Dismukes WE, Duma RJ, Medoff G, Sande MA, Gallis H, Leonard J, et al. A comparison of amphotericin B alone and combined with flucytosine in the treatment of cryptoccal meningitis. N Engl J Med 1979; 301: 126-31. (Trial of amphotericin alone vs its combination with flucytosine in 50 patients with cryptococcal meningitis; “no abnormalities of serum alkaline phosphatase or transaminase were caused by either regimen”). 449951
Stamm AM, Diasio RB, Dismukes WE, Cloud GA, Bowles CA, Karam GH, Espinel-Ingroff A. National Institute of Allergy and Infectious Diseases Mycoses Study Group. Toxicity of amphotericin B plus flucytosine in 194 patients with cryptococcal meningitis. Am J Med 1987; 83: 236-42. (Controlled trial of 4 vs 6 weeks of amphotericin B and flucytosine in 194 patients with cryptococcal meningitis; elevated liver enzymes arose during first 4 weeks in 13 [6.2%] patients, and a 77 year old man with Crohn's disease developed signs and symptoms of hepatitis while on azathioprine as well as flucytosine, dying of acute liver failure one month later; authors attributed liver injury to flucytosine). 3303926
Vermes A, van Der Sijs H, Guchelaar HJ. Flucytosine: correlation between toxicity and pharmacokinetic parameters. Chemotherapy 2000; 46: 86-94. (No correlation was found between pharmacokinetic parameters and likelihood of ALT or Alk P elevations in 53 patients treated with flucytosine and monitored for side effects; in contrast, there was a correlation with thrombocytopenia). 10671757
Vermes A, Guchelaar HJ, Dankert J. Flucytosine: a review of its pharmacology, clinical indications, pharmacokinetics, toxicity and drug interactions. J Antimicrob Chemother 2000; 46: 171-9. (Review of structure, mechanism of action, pharmacokinetics, efficacy and toxicity of flucytosine; reported rates of ALT elevations range from 0-41%, usually reversed with dose reduction and effect may be dose related). 10933638
Song JC, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; wide range of patterns of injury have been reported, typically arising within first month of therapy, may be more common with high plasma levels which can be monitored). 15751740
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 8 cases were attributed to antifungal agents, but no cases were attributed to flucytosine). 18955056
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; mentions that fluctosine has potentially lethal, dose related bone marrow toxicity; no mention of hepatotoxicity). 19940816
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 6 of which were attributed to antifungal agents, but none to flucytosine). 20949552
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 7 due to terbinafine, 6 triazoles, 1 micafungin but none to flucytosine). 25754159
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity, flucytosine being linked to serum enzyme elevations during therapy in a variable proportion of patients and to rare instances of "severe liver necrosis"). 27927037

## OTHER REFERENCE LINKS

1. Recent References on Flucytosine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(flucytosine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=flucytosine) Trials on Flucytosine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=flucytosine)